# Paxlovid

## OVERVIEW

### Introduction

Paxlovid is a co-packaged combination of nirmatrelvir, a second generation protease inhibitor, and ritonavir, a pharmacological enhancer, that is used to treated infection with the severe acute respiratory syndrome coronavirus-2 (SARS-CoV-2) , the cause of the novel and severe coronavirus disease, 2019 (COVID-19). Paxlovid is given orally for 5 days in patients early in the course of infection and has not been linked to serum aminotransferase elevations or to clinically apparent liver injury.

### Background

Paxlovid consists of second generation protease inhibitor (nirmatrelvir) co-packaged with a pharmaceutical enhancer (ritonavir), which is used for oral treatment of recent-onset, mild-to-moderate COVID-19. Nirmatrelvir (ner mat” rel vir) is a peptidomimetic inhibitor of the main protease of SARS-CoV-2: M^pro^ and has antiviral activity in vitro against several coronaviruses including SARS-CoV-1 and -2. Ritonavir (ri toe’ na vir) is a protease inhibitor and potent inhibitor of the enzyme (CYP 3A4) responsible for the metabolism of nirmatrelvir, which allows for higher peak levels and more prolonged half-life of the active antiviral metabolite. In preregistration trials, Paxlovid started within 5 days of symptom onset demonstrated a 89% reduction in subsequent hospitalizations for COVID-19 (1.0% vs 6.7%) and a significant reduction in 28-day mortality (none vs 1.6%). Based upon these results and the ongoing COVID-19 pandemic, Paxlovid was granted Emergency Use Authorization (EUA) in December 2021 as therapy of nonhospitalized patients (adults and children 12 years or older) with documented COVID-19 infection who are at high risk of complications. Paxlovid is available under the EUA as tablets of 150 mg of nirmatrelvir co-packaged with 100 mg tablets of ritonavir; the recommended dose being 2 tablets of nirmatrelvir and one tablet of ritonavir twice daily for 5 days. Longer term therapy is not recommended, nor is therapy recommended for hospitalized patients or patients who have had symptoms or signs for more than 5 days. Currently, Paxlovid is being actively evaluated for efficacy and safety in treating patients not at high risk for complications, for children, and for patients with known exposure to COVID-19 (post-exposure prophylaxis). Paxlovid appears to be generally well tolerated; mild adverse events may include headache, myalgia, gastrointestinal upset, nausea and diarrhea. The total clinical experience with Paxlovid has been limited and its safety not fully defined.

### Hepatotoxicity

In preregistration clinical trials, serum aminotransferase elevations were uncommon and mild, and were no more frequent with Paxlovid than with placebo. Furthermore, among more than 1000 patients treated with Paxlovid (nirmatrelvir 300 mg with ritonavir 100 mg twice daily) for 5 days in prelicensure studies, there were no reported episodes of clinically apparent liver injury. Confounding the issue is that serum aminotransferase elevations are common during symptomatic SARS-CoV-2 infection, present in up to 70% of patients and are more frequent in patients with severe disease and in those with the known risk factors for COVID-19 severity such as male sex, older age, higher body mass index and diabetes. Thus, Paxlovid has not been shown to cause liver injury, but the total clinical experience with its use is limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The lack of adverse events and hepatic injury from Paxlovid may be due to its relatively short duration of therapy. Paxlovid is metabolized by the cytochrome P450 system (largely CYP 3A4) and is given with a CYP 3A4 inhibitor to prolong its half-life and achieve better plasma concentrations and prolong its half-life. However, as a consequence Paxlovid is likely to have significant drug-drug interactions with agents that are metabolized by the CYP 3A4 enzyme. Whether longer term Paxlovid is also without serious adverse events remains to be seen.

Drug Class: Antiviral Agents

Other Drugs in the Subclass: Molnupiravir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nirmatrelvir and Ritonavir – Paxlovid®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Paxlovid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nirmatrelvir | 2628280-40-8 | C23-H32-F3-N5-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 31 January 2022

Abbreviations used: COVID-19, coronavirus disease, 2019; ICU, intensive care unit; IFN, interferon; IL, interleukin; MERS, Middle East respiratory syndrome; NHC, N-hydroxycytidine; SARS-CoV-2, severe acute respiratory syndrome-coronavirus 2.

Huang C, Wang Y, Li X, Ren L, Zhao J, Hu Y, Zhang L, et al. (2020). Clinical features of patients infected with 2019 novel coronavirus in Wuhan, China. Lancet. (Among 41 adults with COVID-19 pneumonia hospitalized in Wuhan China in December 2019-January 2020, 37% had serum AST elevations [62% of those in the ICU and 25% of those not] with concurrent elevations in proinflammatory cytokines [IL1B, IL6, IL2, IFN gamma], and 15% died).
Guan WJ, Ni ZY, Hu Y, Liang WH, Ou CQ, He JX, Liu L, et al. (2020). China Medical Treatment Expert Group for Covid-19. Clinical characteristics of coronavirus disease 2019 in China. N Engl J Med. (Among1099 patients hospitalized with COVID-19 at 552 hospitals in China through January 2020, the median age was 47 years, 42% were women, 2.4% were admitted to an ICU, 1.4% died and ALT elevations arose in 4.1%).
Qiu H, Wander P, Bernstein D, Satapathy SK. (2020). Acute on chronic liver failure from novel severe acute respiratory syndrome coronavirus 2 (SARS-CoV-2). Liver Int. (56 year old woman with decompensated alcoholic cirrhosis developed worsening jaundice and liver function when admitted with SARS-CoV-2 infection [bilirubin rising from 9.4 to ~17.8 mg/dL, ALT from 94 to ~275 U/L, AST from 184 to ~880 U/L, Alk P from 128 to ~195 U/L, INR from 1.92 to 2.6], improving back towards baseline as the infection resolved).
Wander P, Epstein M, Bernstein D. (2020). COVID-19 presenting as acute hepatitis. Am J Gastroenterol. (59 year old woman with HIV infection developed fatigue and jaundice [bilirubin 0.6 mg/dL, ALT 697 U/L, Alk P 145 U/L, INR 1.08] and then developed fever and cough with positive tests for SARS-CoV-1, liver tests falling over the next week as she recovered from COVID-19 ).
Hundt MA, Deng Y, Ciarleglio MM, Nathanson MH, Lim JK. (2020). Abnormal liver tests in COVID-19: A retrospective observational cohort study of 1827 patients in a major U.S. hospital network. Hepatology. (Among 1877 patients hospitalized with SARS-CoV-2 infection, serum ALT levels were elevated before hospitalization in 19%, at admission in 42% and a peak during hospitalization in 62% with 21% being greater than 5 times ULN; elevations correlated with disease severity and its risk factors: male sex, older age, higher BMI and diabetes).
Owen DR, Allerton CMN, Anderson AS, Aschenbrenner L, Avery M, Berritt S, Boras B, et al. (2021). An oral SARS-CoV-2 M^pro^ inhibitor clinical candidate for the treatment of COVID-19. Science. (Development and characterization of a small molecule inhibitor [PF-07321332] of the main protease of SARS-CoV-2, its antiviral activity in several cell culture system; its pharmacology, safety and activity in animal models; and its single dose tolerance and pharmacokinetics with and without CYP 3A4 inhibition [ritonavir] in humans).
Chan HTH, Moesser MA, Walters RK, Malla TR, Twidale RM, John T, Deeks HM, et al. (2021). Discovery of SARS-CoV-2 M^pro^ peptide inhibitors from modelling substrate and ligand binding. Chem Sci. (Biophysical and crystallographic analyses of the main protease [M^pro^] of SARS-CoV-2 and its 11 natural cleavage sites led to design of candidate synthetic peptides with high affinity for the catalytic site that might serve as potent, highly specific M^pro^inhibitors of potential use in therapy of COVID-19).
Wang Z, Yang L. (2021). In the age of Omicron variant: Paxlovid raises new hopes of COVID-19 recovery. J Med Virol. (Letter summarizing the promise held for Paxlovid as an effective therapy for SARS-CoV-2 infection; an orally available, second generation protease inhibitor similar to boceprevir which has activity against multiple coronaviruses including MERS and SARS-CoV-1 and multiple variants of SARS-CoV-2; 8 clinical trials are underway; antiviral resistant mutations in the protease being a critical issue for the future).
Mahase E. (2021). COVID-19: Pfizer's Paxlovid is 89% effective in patients at risk of serious illness, company reports. BMJ. (News reports of the sponsor’s announcement of results of a double-blind, placebo-controlled trial of PF-07321332 [combined with ritonavir] in 1219 adults with confirmed SARS-CoV-2 infection who started treatment within 5 days of symptom onset, showing a reduction in subsequent hospitalization [1% vs 6.7%] and death [none vs 1.8%] from COVID-19).
Couzin-Frankel J. (2021). Antiviral pills could change pandemic's course. Science. (News report of the promise of antivirals including Paxlovid and molnupiravir as a means of treatment for early SARS-CoV-2 infection; no discussion of adverse events).
Paxlovid for treatment of COVID-19. (2022). Med Lett Drug Ther. (Concise review of the mechanism of action, clinical efficacy, safety and indications of Paxlovid shortly after its Emergency Use Authorization in the US mentions only mild adverse events arising during the 5 day treatment including dysgeusia, diarrhea, hypertension, and myalgia; no mention of ALT levels or liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Paxlovid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Paxlovid/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Paxlovid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Paxlovid)